# Nisoldipine

## OVERVIEW

### Introduction

Nisoldipine is a second generation calcium channel blocker and commonly used antihypertensive agent. Nisoldipine therapy is associated with a low rate of serum enzyme elevations, but has not been specifically linked to instances of clinical apparent acute liver injury.

### Background

Nisoldipine (nye sol' di peen) belongs to the dihydropyridine class of calcium channel blockers (similar to amlopdine, felodipine and nifedipine) and is used predominantly for hypertension. Like other calcium channel blockers, nisoldipine acts by blocking the influx of calcium ions into cardiac and vascular smooth muscle cells during membrane depolarization. This action causes relaxation of arterial smooth muscle cells, resulting in arterial vasodilation and a decrease in cardiac work and oxygen consumption. Nisoldipine was approved in the United States in 1995 and current indications are for treatment of hypertension. It is available as extended release tablets of 8.5, 17, 25.5 and 34 mg generically and under the commerical name Sular. The recommended dose in adults is 17 mg once daily, adjusting to 17 to 34 mg per day based upon clinical effects and tolerance. Like other calcium channel blockers, nisoldipine is generally well tolerated, but side effects can include headache, flushing, dizziness, fatigue, nausea, diarrhea, palpitations, peripheral edema and skin rash.

### Hepatotoxicity and Outcome and Management

Nisoldipine has been associated with a low rate of serum aminotransferase or alkaline phosphatase elevations during long term therapy, but the elevations are usually asymptomatic, mild, transient and resolve even with continuation of treatment. Cases of idiosyncratic liver injury due to nisoldipine have not been published. Large trials of nisoldipine have not mentioned liver injury, serum aminotransferase elevations or discontinuation of drug because of hepatic adverse events. Thus, liver injury from nisoldipine must be rare, if it occurs at all.

Likelihood score: E (Unlikely cause of clinically apparent liver injury).

The reason why some calcium channel blockers (such as amlodipine, diltiazem and nifedipine) cause idiosyncratic liver injury while others (such as nisoldipine) do not, is not known. Because liver injury from calcium channel blockers is rare, there may have been inadequate exposures to the uncommonly used agents to lead to clinically manifest cases. Nisoldipine like many calcium channel blockers is metabolized in the liver by CYP 3A4 and is susceptible to drug-drug interactions with substrates, inhibitors and induces of CYP 3A4.

Drug Class: Cardiovascular Agents, Calcium Channel Blockers

Other Drugs in the Subclass, Calcium Channel Blockers: Amlodipine, Diltiazem, Felodipine, Isradipine, Nicardipine, Nifedipine, Nimodipine, Verapamil

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nisoldipine – Generic, Sular®

DRUG CLASS

Cardiovascular Agents

COMPLETE LABELING

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Nisoldipine | 63675-72-9 | C20-H24-N2-O6 | Nisoldipine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 11 January 2017

Zimmerman HJ. Calcium channel blockers. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 646-7. (Expert review of hepatotoxicity published in 1999; among calcium channel blockers, diltiazem, nifedipine, bepridil and verapamil have been incriminated in instances of hepatic injury; nisoldipine is not mentioned).
De Marzio DH, Navarro VJ. Calcium channel blockers. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 524. (Review of hepatotoxicity of calcium channel blockers mentions that diliazem, nifedipine and verapamil have been implicated in causing cholestatic liver injury; nisoldipine is not mentioned).
Michel T, Hoffman BB. Calcium channel antagonists. Treatment of myocardial ischemia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 755-60. (Textbook of pharmacology and therapeutics).
Knorr A. The pharmacology of nisoldipine. Cardiovasc Drugs Ther 1987; 1: 393-402. (Review of pharmacology of nisoldipine).3154674
Friedel HA, Sorkin EM. Nisoldipine. A preliminary review of its pharmacodynamic and pharmacokinetic properties, and therapeutic efficacy in the treatment of angina pectoris, hypertension and related cardiovascular disorders. Drugs 1988; 36: 682-731. (Review of pharmacology, efficacy and safety of nisoldipine; side effects are largely due to the vasodilating activty of nisoldipine, and in clinical trials no "clinically important" biochemical laboratory changes occurred). 3065058
Frishman WH, Heiman M. Usefulness of oral nisoldipine for stable angina pectoris. The Nisoldipine Multicenter Angina Study Group. Am J Cardiol 1991; 68: 1004-9. (Controlled trial of 5 week course of one of 3 doses of nisoldipine vs placebo in 178 patients with angina pectoris, only minor side effects occurred and no mention is made of liver injury or ALT elevations). 1927911
Mitchell J, Frishman W, Heiman M. Nisoldipine: a new dihydropyridine calcium-channel blocker. J Clin Pharmacol 1993; 33: 46-52. (Review of structure, pharmacodynamics, clinical efficacy and safety of nisoldipine, "Side effects... appear to be dose-related, mild in severity and transient"; no mention is made of ALT elevations or liver injury). 8429113
DEFIANT-II Research Group. Doppler flow and echocardiography in functional cardiac insufficiency: assessment of nisoldipine therapy. Results of the DEFIANT-II Study. Eur Heart J 1997; 18: 31-40. (Trial of 6 month course of nisoldipine in 542 patients reported no hepatic adverse events or withdrawals due to liver complications). 9049513
Fodor JG. Nisoldipine CC: efficacy and tolerability in hypertension and ischemic heart disease. Cardiovasc Drugs Ther 1997; 10: (Suppl 3): 873-9. (Nisoldipine is available in an extended release formulation that has favorable pharmokinetics allowing once daily administration, with tolerability that is similar to other calcium channel blockers and "no significant changes in laboratory parameters"). 9126676
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to a calcium channel blocker). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Summary of 25 years of adverse drug reaction reporting in Sweden identified 103 cases of drug induced acute liver failure; only one case was possibly linked to a calcium channel blocker: felodipine). 16165719
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, calcium channel blockers were implicated as a sole agent in 2 cases [1 amlodipine, 1 verapamil] and as one of several agents in 2 cases [both amlodipine]). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but no case was attributed to nisoldipine or other calcium channel blockers). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to a calcium channel blocker or other antihypertensive medication). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases; one case was attributed to verapamil, but none were linked to nisoldipine or other calcium channel blockers). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 39 [4%] were due to antihypertensive agents including 4 due to calcium channel blockers [amlodipine in 1 and verapamil in 3 instances], but none to nisoldipine). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Nisoldipine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=nisoldipine/TU+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Nisoldipine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=nisoldipine)